# Hydroxychloroquine

## OVERVIEW

### Introduction

Hydroxychloroquine is a derivative of chloroquine that has both antimalarial and antiinflammatory activities and is now most often used as an antirheumatologic agent in systemic lupus erythematosis and rheumatoid arthritis. Hydroxychloroquine therapy has not been associated with liver function abnormalities and is an extremely rare cause of clinically apparent acute liver injury.

### Background

Hydroxychloroquine (hye drox" ee klor' oh kwin) is a hydroxylated derivative of chloroquine and has similar antimalarial activity but is less toxic, allowing for use in higher doses for longer periods. Originally used as an antimalarial agent, hydroxychloroquine was later found to have antiinflammatory activity. Its mechanism of action is not well known, but it is concentrated in lysosomes and appears to stabilize lysosomal membranes inhibiting phagocytosis and release of proinflammatory lysosomal enzymes and cytokines. Hydroxychloroquine was approved for use in the United States in 1994, and indications were later broadened and now include rheumatoid and psoriatic arthritis, discoid and systemic lupus erythematosus and prevention and treatment of malaria. Hydroxychloroquine has also been used as therapy of porphyria cutanea tarda where it seems to act by increasing excretion of porphyrins. Hydroxychloroquine is available in generic forms and under the brand names of Plaquenil in tablets of 200 mg. The usual dose is 400 mg daily in one or two divided doses. Common side effects include headaches, dizziness, gastrointestinal upset and rash. Retinopathy is a serious side effect of hydroxychloroquine and regular ophthalmologic monitoring is recommended for patients on long term therapy.

In cell culture systems, hydroxychloroquine and chloroquine have been shown to have a spectrum of antiviral activity that is believed to be due to interference with viral binding to glycoprotein cell receptors or inhibition of endosomal pH regulation. Indeed, both hydroxychloroquine and chloroquine were found to inhibit replication of several viruses including the novel coronavirus known as Severe Acute Respiratory Syndrome coronavirus-type 2 (SARS-CoV-2), the cause of the global pandemic of respiratory illness that was first recognized in late 2019 (COVID-19). In face of the growing burden of severe illness posed by COVID-19, chloroquine and hydroxychloroquine were proposed as possibly effective in preventing or ameliorating the course and prevent mortality. In several case reports, case series and open label trials of these agents yielded evidence of benefit, but in more carefully designed, larger trials neither hydroxychloroquine nor chloroquine given daily for 3 to 5 days had any effect in either preventing infection or ameliorating its outcome.

### Hepatotoxicity

Hydroxychloroquine has not been associated with significant serum enzyme elevations during therapy of rheumatologic diseases. Furthermore, clinically apparent liver injury from hydroxychloroquine is rare. A single case series (two cases) of acute liver failure attributed to hydroxychloroquine was published twenty years ago, but case reports of clinically apparent liver injury have not appeared subsequently. Thus, acute liver injury with jaundice due to hydroxychloroquine must be very rare, if it occurs at all. In clinical trials of hydroxychloroquine for COVID-19 prevention and treatment, there were no reports of hepatotoxicity and rates of serum enzyme elevations during hydroxychloroquine treatment were low and similar to those in patients receiving placebo or comparator agents.

An exception to this is the use of hydroxychloroquine in patients with porphyria cutanea tarda. When used in relatively high doses, hydroxychloroquine can trigger an acute hepatic injury with sudden onset of fever and marked serum enzyme elevations with increased excretion of porphyrins. This reaction appears to be caused by the sudden mobilization of porphyrins and is often followed by an improvement in porphyric symptoms. The reaction is uncommon if therapy is started with lower doses of hydroxychloroquine and is less severe than similar reactions that occur with chloroquine. Indeed, chronic low doses of hydroxychloroquine (100 to 200 mg twice weekly) have been used to alleviate symptoms in patients with prophyria cutanea tarda who are resistant or intolerant of phlebotomy, the usual therapy of this condition.

Likelihood score: C (probable rare cause of idiosyncratic, clinically apparent liver injury, but capable of causing acute hepatoxicity with moderately high doses in patients with porphyria).

### Mechanism of Injury

Hydroxychloroquine is metabolized in the liver and may alter metabolism of other medications. Therapy is unlikely to cause liver injury in normal individuals, but can trigger an acute worsening of porphyria cutanea tarda in susceptible individuals.

Drug Class: Antirheumatic Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Hydroxychloroquine – Generic, Plaquenil®

DRUG CLASS

Antirheumatic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Hydroxychloroquine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Hydroxychloroquine | 118-42-3 | C18-H26-Cl-N3-O

## ANNOTATED BIBLIOGRAPHY

References updated: 15 April 2021

Abbreviations: ANA, antinuclear antibody; HCQ, hydroxychloroquine; Pe, d-penicillamine; SLE, systemic lupus erythematosus.

Zimmerman HJ. Hydroxychloroquine. Drugs used in rheumatic and musculospastic diseases. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, p. 543. (Review of hepatotoxicity published in 1999 mentions that hydroxychloroquine has been widely used with scant evidence of hepatic injury, citing a single case report: Makin et al. 1994).
Vinetz JM, Clain J, Bounkeua V, Eastman RT, Fidock D. Quinolines and related compounds. Chemotherapy of malaria. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1402-5. (Textbook of pharmacology and therapeutics).
Linden IH, Steffen CG, Newcomer VD, Chapman M. (1954). Development of porphyria during chloroquine therapy for chronic discoid lupus erythematosus. Calif Med. (48 year old with discoid lupus developed acute porphyria 3 days after starting chloroquine with fever and uroporphyrins in urine).
Cripps DJ, Curtis AC. (1962). Toxic effect of chloroquine on porphyria hepatica. Arch Dermatol. (3 patients with porphyria had exacerbation of disease 3-4 days after starting chloroquine with fever, tachycardia, elevation in Alk P levels and increase in porphyrin excretion, with rapid improvement on stopping).
Sweeney GD, Saunders SJ, Dowdle EB, Eales L. (1965). Effects of chloroquine on patients with cutaneous porphyria of the "symptomatic" type. Br Med J. (Administration of chloroquine to 9 patients with porphyria led to fever and AST elevations [as high as 2000 U/L] and mild increases in serum bilirubin in association with increased porphyrin excretion).
Felsher BF, Redeker AG. (1966). Effect of chloroquine on hepatic uroporphyrin metabolism in patients with porphyria cutanea tarda. Medicine (Baltimore). (Chloroquine caused a 3.5 to 28 fold increase in uroporphyrin excretion, usually accompanied by fever and ALT elevations [48-69 U/L], with centrolobular necrosis on liver biopsy; thereafter, patients were refractory to the side effects and treatment often induced a clinical remission).
Di Maio VJ, Henry LD. (1974). Chloroquine poisoning. South Med J. (Analysis of 27 cases of fatal overdose of chloroquine from the files of the Armed Forces Institute of Pathology, 13 suicidal, 9 accidental, 1 homicidal and 4 unknown; 6 in children ages 1 to 4 years, rapid onset of vomiting, respiratory difficulties and convulsions; largely cardiotoxic).
Thornsvard CT, Guider BA, Kimball DB. (1976). An unusual reaction to chloroquine-primaquine. JAMA. (39 year old developed fever, abdominal pain, myalgias and red urine 2 days after starting chloroquine-primaquine prophylaxis for malaria, with AST >300 U/L, bilirubin 0.8 mg/dL, Alk P 60 U/L; porphyrin testing indicated an underlying porphyria cutanea tarda).
Malkinson FD, Levitt L. (1980). Hydroxychloroquine treatment of porphyria cutanea tarda. Arch Dermatol. (6 patients with porphyria cutanea tarda treated with hydroxychloroquine in low doses initially, then escalating found no symptomatic liver injury, jaundice or significant ALT elevations [not routinely monitored], all patients had remission but most relapsed on stopping).
Cainelli T, Di Padova C, Marchesi L, Gori G, Rovagnati P, Podenzani SA, Bessone E, Cantoni L. (1983). Hydroxychloroquine versus phlebotomy in the treatment of porphyria cutanea tarda. Br J Dermatol. (Controlled trial of hydroxychloroquine [HCQ: 400 mg daily] vs twice monthly phlebotomy in 61 patients with porphyria cutanea tarda; ALT levels decreased with therapy; porphyrin excretion greater with HCQ, but worsening liver histology in both groups).
Brewer EJ, Giannini EH, Kuzmina N, Alekseev L. (1986). Penicillamine and hydroxychloroquine in the treatment of severe juvenile rheumatoid arthritis. Results of the U.S.A.-U.S.S.R. double-blind placebo-controlled trial. N Engl J Med. (Randomized trial of penicillamine [Pe] vs hydroxychloroquine [HCQ] vs placebo in 122 children with juvenile rheumatoid arthritis found minimal efficacy of HCQ; "marked" elevations in ALT occurred in 10% on PE, 18% on HCQ and 7% on placebo, all resolving without dose modification and perhaps due to concurrent use of aspirin or nonsteroidal antiinflammatory agents).
Rynes RI. (1988). Hydroxychloroquine treatment of rheumatoid arthritis. Am J Med. (Review of trials of hydroxychloroquine in rheumatoid arthritis; complete or partial remissions in 30-50% of patients, delay in response is typical; no mention of hepatotoxicity).
Fox RI, Chan E, Benton L, Fong S, Friedlaender M, Howell FV. (1988). Treatment of primary Sjogren's syndrome with hydroxychloroquine. Am J Med. (Hydroxychloroquine lowers levels of IgG and IgA and decreases some autoantibody titers; no mention of adverse events).
Zvaifler NJ. (1988). Summary. Update in rheumatology–focus on hydroxychloroquine. Am J Med. (Summary of meeting on evidence for efficacy of hydroxychloroquine in rheumatic diseases; no discussion of hepatotoxicity).
Kemmenoe AV. (1990). An infant fatality due to hydroxychloroquine poisoning. J Anal Toxicol. (2 year old swallowed 60 tablets of hydroxychloroquine [12 grams] and had seizures and cardiorespiratory arrest; no hepatic injury mentioned).
Singh G, Fries JF, Williams CA, Zatarain E, Spitz P, Bloch DA. (1991). Toxicity profiles of disease modifying antirheumatic drugs in rheumatoid arthritis. J Rheumatol. (Analysis of side effects of 7 agents from the ARAMIS database, including 2,479 patients [554 on hydroxychloroquine] with rheumatoid arthritis reported 3 instances of liver abnormalities, but no jaundice during ~824 patient years of exposure).
Petersen CS, Thomsen K. (1992). High-dose hydroxychloroquine treatment of porphyria cutanea tarda. J Am Acad Dermatol. (72 patients with porphyria cutanea tarda were treated with hydroxychloroquine 250 mg thrice daily for 3 days; AST elevations occurred during first few days, some rising above 1000 U/L, bilirubin rising above normal in ~30%, all resolving).
Williams HJ, Egger MJ, Singer JZ, Willkens RF, Kalunian KC, Clegg DO, Skosey JL, et al. (1994). Comparison of hydroxychloroquine and placebo in the treatment of the arthropathy of mild systemic lupus erythematosus. J Rheumatol. (Among 71 patients with systemic lupus erythematosus [SLE] randomized to hydroxychloroquine or placebo for 48 weeks, two on drug withdrew because of rash; no mention of ALT elevations or hepatotoxicity).
Makin AJ, Wendon J, Fitt S, Portmann BC, Williams R. (1994). Fulminant hepatic failure secondary to hydroxychloroquine. Gut. (Two cases; 27 year old with SLE developed nausea after 2 weeks of hydroxychloroquine with bilirubin 9.4 mg/dL, ALT 2575 U/L, INR 3.3 progressive liver failure and death in 4 days; 16 year old with juvenile rheumatoid arthritis developed jaundice after 2 weeks of hydroxychloroquine with bilirubin 24.4 mg/dL, AST 544 U/L and renal failure, underwent liver transplant but died 6 days later).
Liu AC. (1995). Hepatotoxic reaction to chloroquine phosphate in a patient with previously unrecognized porphyria cutanea tarda. West J Med. (61 year old developed nausea and fever 1 day after single dose of chloroquine with red urine, ALT 2724 U/L, Alk P 115 U/L, bilirubin 1.1 mg/dL, later diagnosed as having porphyria cutanea tarda).
Clegg DO, Dietz F, Duffy J, Willkens RF, Hurd E, Germain BF, Wall B, et al. (1997). Safety and efficacy of hydroxychloroquine as maintenance therapy for rheumatoid arthritis after combination therapy with methotrexate and hydroxychloroquine. J Rheumatol. (121 patients enrolled in trial of 24 weeks of combination of methotrexate and hydroxychloroquine followed by maintenance therapy with hydroxycloroquine alone or with methotrexate; no clinically apparent liver injury; ALT levels not mentioned).
Mok MY, Ng WL, Yuen MF, Wong RW, Lau CS. (2000). Safety of disease modifying anti-rheumatic agents in rheumatoid arthritis patients with chronic viral hepatitis. Clin Exp Rheumatol. (Among 29 Chinese patients with rheumatoid arthritis and chronic hepatitis [23 HBV; 6 HCV], ALT elevations occurred in 41% on hydroxychloroquine, 30% on methotrexate and 14% on gold vs 14% of 94 controls without viral hepatitis).
van Jaarsveld CHM, Jahangier ZN, Jacobs JWG, Blaauw AAM, van Albada-Kuipers GA, ter Borg EJ, Brus HLM, et al. (2000). Toxicity of antirheumatic drugs in a randomized clinical trial of early rheumatoid arthritis. Rheumatology. (Controlled trial of 4 treatment strategies in 419 patients with early rheumatoid arthritis; side effects were common with ALT elevations in 5 on nonsteroidal antiinflammatory agents only, 1 each on gold and hydroxychloroquine, and 20 on methotrexate).
Sarkany RP. (2001). The management of porphyria cutanea tarda. Clin Exp Dermatol. (History, clinical features, pathogenesis, risk factors, complications and management of porphyria cutanea tarda; due to acquired inhibition of hepatic uroprophyrinogen decarboxylase activity caused by iron, estrogens, or chemicals such as hexohexachlorobenzene; "Low dose twice weekly chloroquine [125-250 mg] is the mainstay of therapy").
Petrov AV. (2004). Lik Sprava.
Rossmann-Ringdahl I, Olsson R. (2007). Porphyria cutanea tarda: effects and risk factors for hepatotoxicity from high-dose chloroquine treatment. Acta Derm Venereol. (Retrospective analysis of 57 patients with porphyria cutanea tarda treated with chloroquine [250 mg/day for 7 days]; ALT rose in all averaging 7 times ULN [range 1.1 to 55 times], with symptoms of fever and arthralgias and increase in porphyrin excretion, higher levels in women, followed by remission but relapse during long term follow up).
Giner Galvañ V, Oltra MR, Rueda D, Esteban MJ, Redón J. (2007). Severe acute hepatitis related to hydroxychloroquine in a woman with mixed connective tissue disease. Clin Rheumatol. (26 year old with early rheumatoid arthritis developed fever and nausea within 10 hours of starting hydroxychloroquine, with ALT 285 U/L, LDH 1,478 U/L [no bilirubin or Alk P levels] with rapid resolution, and no recurrence on restarting at a lower dose).
Das SK, Pareek A, Mathur DS, Wanchu A, Srivastava R, Agarwal GG, Chauhan RS. (2007). Efficacy and safety of hydroxychloroquine sulphate in rheumatoid arthritis: a randomized, double-blind, placebo controlled clinical trial – an Indian experience. Curr Med Res Opin. (122 patients with rheumatoid arthritis randomized to hydroxychloroquine or placebo for 8 weeks; 1 patient on placebo developed hepatitis).
Etogo-Asse F, Boemer F, Sempoux C, Geubel A. (2008). Acute hepatitis with prolonged cholestasis and disappearance of interlobular bile ducts following tibolone and Hypericum perforatum (St. John's wort). Case of drug interaction?. Acta Gastroenterol Belg. (57 year old woman with rheumatoid arthritis on hydroxychloroquine for 7 years and tibolone [a synthetic estrogen] for 2 years developed jaundice 10 weeks after starting daily iv infusions of hypericum perforatum [St. John's wort], with bilirubin 6.3 rising to 36 mg/dL, ALT 424 U/L, Alk P 162 U/L and prolonged cholestatic course with paucity of bile ducts on biopsy, but ultimate resolution).
(2012). Advice for travelers. Treat Guidel Med Lett. (Concise guidelines on advice to travelers indicates that chloroquine is the drug of choice for prevention of malaria while visiting chloroquine sensitive areas to start 1-2 weeks before travel and stop 4 weeks after leaving; with specific recommendations available at www.cdc.gov/malaria).
Singal AK, Kormos-Hallberg C, Lee C, Sadagoparamanujam VM, Grady JJ, Freeman DH, Anderson KE. (2012). Low-dose hydroxychloroquine is as effective as phlebotomy in treatment of patients with porphyria cutanea tarda. Clin Gastroenterol Hepatol. (Trial comparing hydroxychloroquine [100 mg twice weekly] to phlebotomy in 48 patients with porphyria cutanea tarda [largely due to hepatitis C] found similar efficacy; transient, asymptomatic ALT elevations >twice baseline occurred in one patient in each treatment arm).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, none of which were attributed to hydroxychloroquine).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, the most common implicated agents being nimesulide [n=53: 30%], cyproterone [n=18], nitrofurantoin [n=17], antituberculosis drugs [n=13] and flutamide [n=12: 7%], but none were attributed to a hydroxychloroquine).
Khellaf M, Chabrol A, Mahevas M, Roudot-Thoraval F, Limal N, Languille L, Bierling P, et al. (2014). Hydroxychloroquine is a good second-line treatment for adults with immune thrombocytopenia and positive antinuclear antibodies. Am J Hematol. (Among 40 patients with idiopathic thrombocytopenic purpura and ANA positivity treated with hydroxychloroquine in addition to standard therapies, 60% had a clinical response and "the overall safety was good" and "no patient stopped treatment because of a side effect"; no mention of ALT elevations or hepatotoxicity).
(2014). Drugs for rheumatoid arthritis. Med Lett Drugs Ther. (Concise summary and recommendations for drug therapy of rheumatoid arthritis mentions hydroxychloroquine as a tolerated and moderately effective agent for mild rheumatoid arthritis, adverse events including nausea and vomiting and more rarely hemolysis [with G6PD deficiency] and retinal toxicity with long term use that calls for ophthalmologic screening and annual exams after 5 years; no mention of ALT elevations or hepatotoxicity).
Abdel Galil SM. (2015). Hydroxychloroquine-induced toxic hepatitis in a patient with systemic lupus erythematosus: a case report. Lupus. (28 year old woman with SLE developed abdominal pain as prednisone doses were decreased after a year of high dose treatment in combination with hydroxychloroquine [ALT 986 U/L, bilirubin and Alk P not provided], with rapid recovery on stopping both agents and switching to mycophenolate).
Pareek A, Chandurkar N, Thulaseedharan NK, Legha R, Agarwal M, Mathur SL, Salkar HR, et al. (2015). Efficacy and safety of fixed dose combination of atorvastatin and hydroxychloroquine: a randomized, double-blind comparison with atorvastatin alone among Indian patients with dyslipidemia. Curr Med Res Opin. (Among 328 patients with hypercholesterolemia treated with atorvastatin with or without hydroxychloroquine for 24 weeks, reductions in LDL cholesterol were greater with the combination [-40% vs -33%] while adverse event rates were similar; no mention of ALT elevations or hepatotoxicity).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 5 cases were attributed to drugs for rheumatoid arthritis [all 5 due to leflunomide], but none to hydroxychloroquine).
Yokogawa N, Eto H, Tanikawa A, Ikeda T, Yamamoto K, Takahashi T, Mizukami H, et al. (2017). Effects of hydroxychloroquine in patients with cutaneous lupus erythematosus: a multicenter, double-blind, randomized, parallel-group trial. Arthritis Rheumatol. (Among 101 patients with cutaneous lupus erythematosus treated with hydroxychloroquine or placebo for 16 weeks followed by single blind period of 55 weeks, changes in clinical activity scores were similar in the two groups and adverse events included skin rash, Stevens-Johnson syndrome and "hepatic dysfunction", although the authors report "no laboratory test values or vital signs showed any clinically significant change during this study in either group").
Wei CH, Penunuri A, Karpouzas G, Fleishman W, Datta A, French SW. (2015). Troxis necrosis, a novel mechanism for drug-induced hepatitis secondary to immunomodulatory therapy. Exp Mol Pathol. (26 year old man with systemic lupus erythematosus treated with hydroxychloroquine, mycophenolate, prednisone and monoclonal anti-TWEAK developed fatigue and serum enzyme elevations [ALT 174 U/L, AStT 305 U/L, with Alk P, CPK and bilirubin not provided] that resolved on withdrawal all medications except prednisone).
Sunkara B, Roofeh D, Silver S, Pearson TL, Ettel M, McCune WJ. (2018). The devil's in the dosing: severe drug-induced liver injury in a hydroxychloroquine-naïve patient with subacute cutaneous lupus erythematosus and porphyria cutanea tarda. Lupus. (29 year old woman with blistering rash on the hands and malar rash with ANA positivity was diagnosed with lupus and started on hydroxychloroquine, developing nausea and dark urine 3 days later with ALT 6480 U/L, AST 4472 U/L [bilirubin and Alk P not given], with elevation in total porphyrins, resolving upon stopping hydroxychloroquine).
Wang M, Cao R, Zhang L, Yang X, Liu J, Xu M, Shi Z, et al. (2020). Remdesivir and chloroquine effectively inhibit the recently emerged novel coronavirus (2019-nCoV) in vitro. Cell Res. (In cell culture, both remdesivir and chloroquine demonstrated potential antiviral activity against SARS-CoV-2 at levels achievable in plasma and with minimal cellular cytotoxicity).
Fantini J, Di Scala C, Chahinian H, Yahi N. (2020). Structural and molecular modelling studies reveal a new mechanism of action of chloroquine and hydroxychloroquine against SARS-CoV-2 infection. Int J Antimicrob Agents. (Molecular modeling of the structures of chloroquine and hydroxychloroquine suggest that they would prevent the binding of the SARS-CoV-2 spike protein to its receptor [angiotensin-converting enzyme receptor] on cell membranes and thus prevent viral attachment and infection).
Geleris J, Sun Y, Platt J, Zucker J, Baldwin M, Hripcsak G, Labella A, et al. (2020). Observational study of hydroxychloroquine in hospitalized patients with Covid-19. N Engl J Med. (In an observational study of 1376 hospitalized patients with COVID-19 pneumonia, hydroxychloroquine therapy [median of 5 days] was associated with higher rates of intubation or death than standard of care [32% vs 15%], but the hazard ratio of these outcomes was not elevated after adjustment for propensity scores at the time of initiation of therapy; no mention of ALT elevations or hepatotoxicity).
Tang W, Cao Z, Han M, Wang Z, Chen J, Sun W, Wu Y, et al. (2020). Hydroxychloroquine in patients with mainly mild to moderate coronavirus disease 2019: open label, randomised controlled trial. BMJ. (Among 150 patients hospitalized with largely mild-to-moderate COVID-19 who were treated with hydroxychloroquine [median 14 days] vs standard of care, time to loss of SARS-CoV-2 RNA was the same in both groups but adverse events were more frequent with hydroxychloroquine [30% vs 9%], which was largely due to gastrointestinal symptoms; ALT elevations occurred in only one patient in both groups).
Boulware DR, Pullen MF, Bangdiwala AS, Pastick KA, Lofgren SM, Okafor EC, Skipper CP, et al. (2020). A Randomized trial of hydroxychloroquine as postexposure prophylaxis for COVID-19. N Engl J Med. (Among 821 patients with exposure to COVID-19 treated with oral hydroxychloroquine or placebo for 5 days, rates of new illness compatible with COVID-19 were similar in the two groups [14% vs 12%] while adverse events were more frequent with hydroxychloroquine [40% vs 17%]; ALT elevations were not mentioned).
Skipper CP, Pastick KA, Engen NW, Bangdiwala AS, Abassi M, Lofgren SM, Williams DA, et al. (2020). Hydroxychloroquine in nonhospitalized adults with early COVID-19 : a randomized trial. Ann Intern Med. (Among 423 symptomatic outpatients with COVID-19 treated with a 5-day course of hydroxychloroquine or placebo, the rates of symptomatic improvement and hospitalization were not different in the two groups, but adverse events were more common with hydroxychloroquine [43% vs 27%], most frequently gastrointestinal upset, nausea, diarrhea and abdominal pain; no mention of ALT elevations or hepatotoxicity).
Cavalcanti AB, Zampieri FG, Rosa RG, Azevedo LCP, Veiga VC, Avezum A, Damiani LP, et al. (2020). Coalition Covid-19 Brazil I Investigators. Hydroxychloroquine with or without azithromycin in mild-to-moderate Covid-19. N Engl J Med. (Among 667 adults hospitalized with COVID-19 [504 confirmed by virologic testing] treated with hydroxychloroquine alone, or combined with azithromycin, or standard of care, improvement in clinical condition using an ordinal scale was similar in all three groups with similar duration of hospitalization [9.6 vs 10.3 vs 9.5 days], mortality [3.1% vs 1.7% vs 2.9%] but high adverse event rates including higher ALT or AST elevations above 3 times ULN with hydroxychloroquine [8.5%] and its combination with azithromycin [10.9%] compared to controls [3.4%]; although there were no severe hepatic adverse events).
RECOVERY Collaborative Group. (2020). Effect of hydroxychloroquine in hospitalized patients with Covid-19. N Engl J Med. (Among 1561 patients randomized to receive hydroxychloroquine vs 3155 randomized to standard care, the mortality rate was similar in the two groups [27% vs 25%] but the duration of hospitalization was longer with hydroxychloroquine [16 vs 13 days], while cardiovascular toxicity was not increased with the active drug, there was no mention of ALT elevations or hepatotoxicity).
Serviddio G, Villani R, Stallone G, Scioscia G, Foschino-Barbaro MP, Lacedonia D. (2020). Tocilizumab and liver injury in patients with COVID-19. Therap Adv Gastroenterol. (Seven patients with severe COVID-19 pneumonia who worsened on usual therapy [hydroxychloroquine, lopinavir/ritonavir] for 5-7 days with serum ALT levels rising [to 49-199 U/L] and who were then treated with tocilizumab, all 7 had a clinical and biochemical response [ALT falling to 28-51 U/L] within 3 weeks).
Melquist S, Estepp K, Aleksandrovich Y, Lee A, Beiseker A, Hamedani FS, Bassett J. (2020). COVID-19 presenting as fulminant hepatic failure: A case report. Medicine (Baltimore). (35 year old woman with SLE previously on hydroxychloroquine and mycophenolate but had stopped therapy because of pregnancy and breast feeding, developed COVID-19 infection with mild cough and acute liver failure [ALT 278 U/L Alk P 200 U/L, bilirubin 7.0 mg/dL, INR 1.5 rising to 4.9] accompanied by hepatic encephalopathy, but responded to restarting hydroxychloroquine and methylprednisolone).
Dauner DG, Dauner KN. Summary of adverse drug events for hydroxychloroquine, azithromycin, and chloroquine during the COVID-19 pandemic. J Am Pharm Assoc (2003). 2021 Jan 11: S1544-3191(21)00008-X. (Review of the FDA adverse drug reports for January to July 2020 for azithromycin, chloroquine and hydrochloroquine, including rise in reports from 592 before to 2492 after their emergency use authorization for COVID-19 infection, mostly for hydroxychloroquine [596] and azithromycin [184], the second most frequent event being “hepatitis”).
Melo JRR, Duarte EC, Moraes MV, Fleck K, Silva ASDNE, Arrais PSD. (2021). Adverse drug reactions in patients with COVID-19 in Brazil: analysis of spontaneous notifications of the Brazilian pharmacovigilance system. Cad Saude Publica. (In Brazil between March and August 2020, a total of 631 adverse event reports in 402 patients with COVID-19 were received between March and August 2020, of which 56 cases [9%] were hepatic including 28 attributed to hydroxychloroquine [2 fatal], 4 azithromycin [1 fatal], and 2 chloroquine [2 fatal].
Solaymani-Dodaran M, Ghanei M, Bagheri M, Qazvini A, Vahedi E, Hassan Saadat S, Amin Setarehdan S, et al. (2021). Safety and efficacy of favipiravir in moderate to severe SARS-CoV-2 pneumonia. Int Immunopharmacol. (Among 373 adults hospitalized with COVID-19 pneumonia treated with favipiravir or lopinavir/ritonavir with standard care [hydroxychloroquine] for 7 days, the duration of hospitalization [7 vs 6 days], need for ICU care [16% vs 14%] and 28 day mortality [14% vs 12%] were the same in the two groups; no mention of ALT elevations or hepatotoxicity).
Axfors C, Schmitt AM, Janiaud P, Van't Hooft J, Abd-Elsalam S, Abdo EF, Abella BS, et al. (2021). Mortality outcomes with hydroxychloroquine and chloroquine in COVID-19 from an international collaborative meta-analysis of randomized trials. Nat Commun. (In a metaanalysis of 14 published and 14 unpublished clinical trials including 26 of hydroxychloroquine [10,319 patients] and 4 of chloroquine [307 patients] as therapy of COVID-19, hydroxychloroquine was associated with an excess mortality and chloroquine with no benefit; no separate analysis of adverse events).
WHO Solidarity Trial Consortium. (2021). Repurposed antiviral drugs for Covid-19 – interim WHO Solidarity Trial results. N Engl J Med. (Among 11,300 hospitalized adults with COVID-19 enrolled in randomized controlled trials of four repurposed drugs vs standard of care, none of the 4 agents resulted in reduced mortality rates compared to controls: remdesivir 11% versus 11.2%; hydroxychloroquine 11% vs 9.3%; lopinavir/ritonavir 10.6% vs 10.6%; and interferon beta 11.9% vs 10.5%; and there were no deaths attributed to hepatic disease).

## OTHER REFERENCE LINKS

1 Recent References on Hydroxychloroquine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Hydroxychloroquine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Hydroxychloroquine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Hydroxychloroquine)